# Enlicitide

## OVERVIEW

### Introduction

Enlicitide is an orally administered PCSK9 inhibitor used to reduce low-density lipoprotein cholesterol (LDL-C) in adults with hypercholesterolemia. Enlicitide has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Enlicitide (en li' si tide) is a macrocyclic peptide that binds to and inhibits proprotein convertase subtilisin/kexin type 9 (PCSK9), a protein that promotes degradation of low-density lipoprotein (LDL) receptors on the surface of hepatocytes. By blocking the interaction of PCSK9 with the LDL receptor, enlicitide increases the number of receptors available to clear LDL-C from the circulation, thereby lowering LDL-C levels. This is the same mechanism of action as the injectable anti-PCSK9 monoclonal antibodies evolocumab and alirocumab, but enlicitide is notable for being the first orally available PCSK9 inhibitor. Each tablet contains the excipient sodium caprate, a permeation enhancer that temporarily increases the permeability of the intestinal epithelium to improve the otherwise low oral absorption of the peptide. In two large placebo-controlled trials in adults with hypercholesterolemia (including those with heterozygous familial hypercholesterolemia) on optimized statin therapy, the addition of enlicitide lowered LDL-C by 55% to 60% relative to placebo, with reductions maintained through 52 weeks; it also lowered apolipoprotein B and lipoprotein(a). Enlicitide was approved for use in the United States in 2026 and is available as 20 mg tablets under the brand name Lipfendra. The recommended dose is 20 mg taken orally once daily. Common side effects include diarrhea and dizziness. Other adverse events reported at rates similar to placebo included nasopharyngitis, upper respiratory tract infection, headache, and influenza. Because enlicitide lowers cholesterol and possibly other biologically active substances derived from cholesterol, it may cause fetal harm and should be discontinued when pregnancy is recognized.

### Hepatotoxicity

In the two pre-registration, 52-week placebo-controlled trials (with a combined safety population of over 3,000 participants), which provided the data on efficacy and safety for its FDA approval, the frequencies of adverse events, serious adverse events, and discontinuations due to side effects were similar between enlicitide and placebo. Serum elevations of ALT and AST above 3 times the upper limit of normal (ULN) occurred in fewer than 1% of patients, a rate similar to that in placebo recipients. No patient developed clinically apparent liver injury. Since its approval there have been no published cases of drug induced liver injury attributed to its use, although clinical experience with enlicitide has been limited and its long-term efficacy and safety have yet to be defined.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which enlicitide might cause liver injury is unknown, but the likelihood of hepatic injury appears low. Enlicitide is a macrocyclic peptide that is minimally metabolized, with no major metabolites identified, and is eliminated largely unchanged by renal excretion, so accumulation of a hepatotoxic metabolite is unlikely. It does not inhibit or induce the major cytochrome P450 enzymes to a meaningful extent nor does it inhibit hepatic transporters at clinically relevant concentrations, and is not expected to cause clinically important drug-drug interactions.

### Outcome and Management

Enlicitide has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury, and no specific recommendations for monitoring of liver tests during therapy have been made. There is no known cross-reactivity of liver injury between enlicitide and other agents used to lower LDL-C, and patients who develop liver-related abnormalities on other lipid-lowering therapies would not be expected to have similar problems with enlicitide.

Drug Class: Antilipemic Agents; PCSK9 Inhibitors

Other Drugs in the Subclass: Alirocumab; Evolocumab; Inclisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enlicitide – Lipfendra®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Enlicitide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Enlicitide decanoate | 2407527-14-2 | C82H110FN14O15 | SID: 471409643

## ANNOTATED BIBLIOGRAPHY

References updated: 27 August 2026

Abbreviations used: ASCVD, atherosclerotic cardiovascular disease; HeFH, heterozygous familial hypercholesterolemia; LDL-C, low-density lipoprotein cholesterol; PCSK9, proprotein convertase subtilisin/kexin type 9; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, before the availability of enlicitide or other PCSK9 inhibitors.)
Rosenson RS, Durrington P. Lipid lowering with drugs other than statins and fibrates. In, Brunton LL, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 14th ed. New York: McGraw-Hill, 2023. (Textbook of pharmacology and therapeutics, published before the availability of enlicitide.)
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2026/220848Orig1s000MultidisciplineR.pdf (FDA website with the product label and multidisciplinary review of the efficacy and safety of enlicitide, based upon data submitted by the sponsor in support of its approval as therapy of hypercholesterolemia; states that no participants met predefined criteria for potential drug-induced liver injury in the placebo-controlled pool, that elevations of ALT or AST above 3 times ULN occurred in fewer than 1% of participants at rates comparable to placebo, and that no clinically meaningful differences in liver-associated laboratory values were observed between the enlicitide and placebo groups.)
Navar AM, Mikhailova E, Catapano AL, Banka P, Blom DJ, Cadena A, Kourpanidis S, et al.; A placebo-controlled trial of the oral PCSK9 inhibitor enlicitide. N Engl J Med. 2026;394:529-539. PMID: (Among 2,904 adults with or at risk for a major ASCVD event and elevated LDL-C treated for 52 weeks with oral enlicitide [20 mg daily] or placebo added to background statin therapy, LDL-C fell by 56% more with enlicitide than with placebo at week 24; the incidence of adverse events did not appear to differ between groups, no participant met criteria for drug-induced liver injury; no mention of hepatotoxicity or ALT elevations). 41879224
Ballantyne CM, Gellis L, Tardif JC, Banka P, Navar AM, Asprusten EA, Scott R, et al. Efficacy and safety of oral PCSK9 inhibitor enlicitide in adults with heterozygous familial hypercholesterolemia: a randomized clinical trial. JAMA. 2026;335:129-139. PMID: (Among 303 adults with heterozygous familial hypercholesterolemia on stable statin therapy treated for 52 weeks with oral enlicitide [20 mg daily] or placebo, LDL-C fell by 59% more with enlicitide than with placebo at week 24; the most common adverse events were diarrhea [7% vs 2%] and dizziness [7% vs 4%], there were no clinically meaningful between-group differences in liver test results, and no participant met criteria for drug-induced liver injury.) 41206969
Catapano AL, Mikhailova E, Navar AM, Banka P, Corral P, Saxena M, Steg PG, et al.; Oral PCSK9 inhibitor enlicitide versus oral nonstatin therapies: a phase 3 randomized clinical trial. J Am Coll Cardiol. 2026;88:340-352. PMID: (Among 301 statin-treated adults with a history of or at increased risk for a major ASCVD event, enlicitide lowered LDL-C by 64.6% at day 56, more than bempedoic acid, ezetimibe, or their combination; rates of adverse events and discontinuations were similar across arms, no participant met protocol-defined criteria for drug-induced liver injury, and hepatotoxicity was not reported.) 42017875
Johns DG, Campeau LC, Banka P, Bautmans A, Bueters T, Bianchi E, Branca D, et al. Orally bioavailable macrocyclic peptide that inhibits binding of PCSK9 to the low density lipoprotein receptor. Circulation. 2023;148:144-158. PMID: (Description of the discovery and preclinical pharmacology of enlicitide [MK-0616], an orally bioavailable macrocyclic peptide that inhibits PCSK9 binding to the LDL receptor with potency comparable to that of monoclonal antibodies; no discussion of hepatotoxicity.) 37125593
Ballantyne CM, Banka P, Mendez G, Garcia R, Rosenstock J, Rodgers A, Mendizabal G, et al. Phase 2b randomized trial of the oral PCSK9 inhibitor MK-0616. J Am Coll Cardiol. 2023;81:1553-1564. PMID: (Among 380 adults with hypercholesterolemia treated for 8 weeks with enlicitide capsules [6, 12, 18, or 30 mg] or placebo, placebo-corrected reductions in LDL-C ranged from 41% to 61%, with a similar incidence of adverse events and serious adverse events between treatment groups and no mention of ALT elevations or hepatotoxicity.) 36889610
Müller-Kozarez I, Laufs U. Phase 3 study results for oral PCSK9 inhibition with enlicitide. Med. 2026;7:101097. PMID: (Brief review of the data on safety and efficacy of enlicitide with description of its molecular structure, mechanism of action, absorption, and role in management of hypercholesterolemia as well as an overview of future long-term clinical trials of enlicitide and the possible future role of gene therapy). 41966715
Josien H, Nair AG, Ding FX, Guo Y, Chen YH, Rao AU, Liu J, et al. Discovery process of enlicitide, a highly engineered macrocyclic peptide therapeutic, through issue-driven fragment-based synthetic assembly and SAR. J Med Chem. 2026;69:13473-13491. PMID: (Description of the history of discovery and molecular design of enlicitide, a macrocyclic peptide, optimized by SAR: structural-activity-relationship). 42201324
Enlicitide (Lipfendra) - an oral PCSK9 inhibitor for LDL-cholesterol lowering. Med Lett Drugs Ther. 2026;68(1762):137-139. PMID: (Concise review of the mechanism of action, clinical efficacy, safety, and cost of enlicitide shortly after its approval; notes that diarrhea and dizziness have been reported and that cardiovascular outcomes data are lacking but does not mention ALT elevations or hepatotoxicity). 42628979

## OTHER REFERENCE LINKS

1. Recent References on Enlicitide from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Enlicitide%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Enlicitide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enlicitide)